# Royal Jelly

## OVERVIEW

### Introduction

Royal jelly is a milk-like secretion of honey bees that is used to feed larvae for 3 days for the worker bees and drones and until full development for the queen. Royal jelly has been used widely as a dietary supplement for its purported health prompting properties. Royal jelly is generally well tolerated and has not been linked to serum aminotransferase elevations during therapy or to instances of clinically apparent liver injury.

### Background

Royal jelly is a milk-like secretion of honey bees (Apis mellifera) that is used to feed larvae in the honeycomb. Larvae that are to develop into drones (males) or worker bees (infertile females) are fed directly and for 3 days only. Larvae that are to become queens (fertile females) are fed the royal jelly secretions in large amounts and until they are fully developed. Royal jelly is harvested from the individual queen bee cells in honey bee hives and used as an emollient in topical creams as well as a dietary supplement for purported medicinal properties. Royal jelly consists of water, proteins, amino acids, fatty acids, simple carbohydrates, vitamins and minerals. The active component that stimulates and modulates larval development is believed to be a series of “major royal jelly proteins” (MRJP). These MRJP alter DNA methylation resulting in an epigenic, nutritionally-driven change in expression of genes responsible for larva development. Royal jelly is used topically in creams and orally in dietary supplements purported to be beneficial for general health and well being. The bases of these claims have not been substantiated, but in vitro and animal studies suggest that components of royal jelly have antiinflammatory and antioxidant properties. Royal jelly is generally well tolerated without adverse events except for rare allergic reactions particularly in patients with a history of asthma or atopic disease. The hypersensitivity reactions can include urticaria, pruritus, erythema, laryngeal edema, wheezing, chest tightness, hypotension, cardiovascular collapse, and in rare instances death. The reactions arise within minutes of ingestion are most likely due to allergy to one of the major royal jelly proteins.

Other names: Jalea Real, Bee Saliva, Honey Bee Milk

### Hepatotoxicity

Liver injury attributable to royal jelly has not been reported. In clinical trials of royal jelly as therapy of various conditions, side effects were rarely mentioned and ALT elevations and hepatotoxicity were not reported. Despite availability and widespread use as an alternative therapy, there have been no published reports of royal jelly induced liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Royal jelly has many components, but none of them has been shown to be particularly hepatotoxic.

### Outcome and Management

Hepatotoxicity from royal jelly has not been reported.

Drug Class: Herbal and Dietary Supplements, Bee Products

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Royal Jelly – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Royal Jelly | 8031-67-2 | Apitherapy | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: May 1, 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not royal jelly).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of royal jelly).
Leung R, Thien FC, Baldo B, Czarny D. (1995). Royal jelly-induced asthma and anaphylaxis: clinical characteristics and immunologic correlations. J Allergy Clin Immunol. (Among 7 patients [6 women, 1 man, ages 19 to 66 years] with hypersensitivity reactions to oral royal jelly [in liquid and capsule forms] usually with acute severe attacks of asthma or anaphylaxis within minutes of ingestion, all had positive skin prick tests as well as IgE antibody that reacted with royal jelly protein extracts).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation; no mention of royal jelly).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma huang [3], pennyroyal [1], skullcap [2], Chinese herbs [9], valerian [1]; royal jelly is not mentioned).
Testi S, Cecchi L, Severino M, Manfredi M, Ermini G, Macchia D, Capretti S, et al. (2007). Severe anaphylaxis to royal jelly attributed to cefonicid. J Investig Allergol Clin Immunol. (28 year old man with long-standing asthma developed dyspnea, wheezing, cough and chest tightness shortly after ingesting royal jelly on two occasions was found to have a positive skin test to royal jelly).
Katayama M, Aoki M, Kawana S. (2008). Case of anaphylaxis caused by ingestion of royal jelly. J Dermatol. (26 year old Japanese woman with a history of asthma, atopic dermatitis and food allergies developed anaphylaxis, generalized erythema and swelling of lips 5 minutes after ingesting a beverage of crude royal jelly with progressive respiratory distress requiring temporary intubation).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, none due to royal jelly).
Münstedt K, Bargello M, Hauenschild A. (2009). Royal jelly reduces the serum glucose levels in healthy subjects. J Med Food. (In 20 healthy volunteers undergoing 2 glucose tolerance tests one week apart, the second after a single 20 gm dose of royal jelly, glucose levels were slightly lower after the royal jelly but insulin and C-peptide levels were similar).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found none attributed to royal jelly).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not royal jelly).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements does not include any attributed to royal jelly).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does no mention royal jelly).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but none were attributed to royal jelly).
Paola F, Pantalea DD, Gianfranco C, Antonio F, Angelo V, Eustachio N, Elisabetta DL. (2014). Oral allergy syndrome in a child provoked by royal jelly. Case Rep Med. (A 7 year old healthy child developed oral allergy symptoms on 2 occasions 10 minutes after ingestion of royal jelly with lip and tongue edema and palate itching).
Taavoni S, Barkhordari F, Goushegir A, Haghani H. (2014). Effect of Royal Jelly on premenstrual syndrome among Iranian medical sciences students: a randomized, triple-blind, placebo-controlled study. Complement Ther Med. (Among 110 female medical studies students with premenstrual syndrome treated with royal jelly capsules [1000 mg] or placebo once daily] for two menstrual cycles, symptoms decreased with royal jelly but not placebo; no mention of adverse events).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not discuss royal jelly specifically).
Lambrinoudaki I, Augoulea A, Rizos D, Politi M, Tsoltos N, Moros M, Chinou I, et al. (2016). Greek-origin royal jelly improves the lipid profile of postmenopausal women. Gynecol Endocrinol. (Among 36 postmenopausal women treated with oral royal jelly [150 mg] daily for 3 months, serum HDL cholesterol levels increased [60 to 65 mg/dL] while LDL cholesterol decreased slightly [144 to 136 mg/dL]; no mention of adverse events or changes in serum ALT levels).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while none were attributed to royal jelly).
Sharif SN, Darsareh F. (2019). Effect of royal jelly on menopausal symptoms: A randomized placebo-controlled clinical trial. Complement Ther Clin Pract. (Among 200 postmenopausal woman treated with royal jelly [1000 mg] or placebo once daily for 8 weeks, menopausal symptoms improved with royal jelly therapy but not placebo; no mention of adverse events).
Lima WG, Brito JCM, da Cruz Nizer WS. (2021). Bee products as a source of promising therapeutic and chemoprophylaxis strategies against COVID-19 (SARS-CoV-2). Phytother Res. (Review of the preclinical and clinical evidence for the activity of bee products [including royal jelly, beeswax, bee pollen, bee venom and propolis] against SARS-CoV-2; no mention of adverse events).
Matsushita H, Shimizu S, Morita N, Watanabe K, Wakatsuki A. (2021). Effects of royal jelly on bone metabolism in postmenopausal women: a randomized, controlled study. Climacteric. (Among 72 postmenopausal women treated with royal jelly [3000 mg daily] or placebo for 6 months, bone mineral density did not change in those receiving royal jelly but decreased to some extent in those on placebo; no mention of adverse events).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb-induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Hou Wu [91], green tea [90], Herbalife products [64], kava kava [62], greater celandine [48], and aloe vera [22], but royal jelly was not mentioned).
Li JD, Cui L, Xu YY, Guan K. (2021). A case of anaphylaxis caused by major royal jelly protein 3 of royal jelly and its cross-reactivity with honeycomb. J Asthma Allergy. (56 year old Chinese woman developed two episodes of anaphylaxis with urticaria, pruritus, laryngeal edema, hypotension and collapse within 1 hour of consuming royal jelly and was found to have a positive skin prick test to crude extracts of royal jelly; immunoblotting with her serum identified evidence of antibodies to purified royal jelly protein 3).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3] while none were attributed to royal jelly).
El-Seedi HR, Eid N, Abd El-Wahed AA, Rateb ME, Afifi HS, Algethami AF, Zhao C, et al. (2022). Honey bee products: preclinical and clinical studies of their anti-inflammatory and immunomodulatory properties. Front Nutr. (Extensive review of the preclinical and clinical studies of honey bee products including royal jelly, beeswax and bee pollen; no mention of adverse event rates or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Royal Jelly: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Royal+Jelly+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Royal Jelly: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Royal%20Jelly)